# Lamivudine

## OVERVIEW

### Introduction

Lamivudine is a nucleoside analogue and reverse transcriptase inhibitor used in the therapy of human immunodeficiency virus (HIV) and hepatitis B virus (HBV) infection. Lamivudine is a very rare cause of clinically apparent drug induced liver injury, but is associated with flares of underlying hepatitis B during therapy or with abrupt withdrawal.

### Background

Lamivudine (la miv' ue deen) is an L-enantiomer and substituted analogue of cytidine (2’,3’-dideoxy-3’-3-thiacytidine: 3TC) and is active against both HIV and HBV in vitro and in vivo. Lamivudine is phosphorylated intracellularly to the triphosphate which competes with the naturally occurring cytidine triphosphate for incorporation into the growing HIV or HBV DNA chain by the viral polymerase, thereby inhibiting polymerase (or reverse transcriptase) activity and causing chain termination. Lamivudine is indicated for the treatment of HBV infection as a single agent and for HIV infection in combination with other HIV medications. For HIV infection, lamivudine is available as 150 and 300 mg tablets and as oral solutions under the trade name Epivir. Lamivudine is also available in multiple fixed combinations with other antiretroviral agents such as zidovudine, abacavir, tenofovir, efavirenz, nevirapine, dolutegravir and others. The recommended dose of lamivudine for HIV infection in adults is 150 mg twice daily or 300 mg once daily. For HBV infection the recommended dose of lamivudine in adults is 100 mg orally once daily, the drug being available in this dose under the trade name Epivir-HBV. Lamivudine was approved by the FDA for HIV infection in 1995 and for HBV infection in 1998. Lamivudine is currently used in many HAART regimens but is now rarely used to treat hepatitis B because of a high rate of antiviral resistance when it is used as monotherapy as well as the availability of more potent agents with a higher barrier to resistance. Side effects of lamivudine are uncommon but may include headache, nausea, fatigue diarrhea and cough. Severe adverse events occur largely when it is withdrawn in patients with chronic hepatitis B or with the development of antiviral resistance.

### Hepatotoxicity

Elevations in serum ALT levels occur in a proportion of patients with chronic hepatitis B treated with lamivudine. These elevations appear to be due to a transient flare in the underlying chronic hepatitis B and occur in three situations during and after therapy: upon initiation of therapy (treatment flares), upon development of antiviral resistance (breakthrough flares), and shortly after stopping therapy (withdrawal flares). Treatment flares typically occur during the first few months of therapy and are marked by asymptomatic elevations in serum aminotransferase levels and rarely with jaundice or symptoms (Case 1). These flares occur during the rapid decrease in HBV DNA levels with initiation of therapy. An exacerbation of hepatitis also typically occurs after development of lamivudine resistance, a few weeks or months after the initial appearance of the mutant HBV strain and rise in HBV DNA levels (Case 2). Finally, withdrawal flares occur between 4 and 12 weeks after stopping lamivudine and can be severe, symptomatic and even lead to clinical decompensation, acute liver failure and either death or need for emergency liver transplantation. Resistance and withdrawal flares typically occur as HBV DNA levels are high or rising.

Other forms of hepatotoxicity from lamivudine are extremely rare if they occur at all. Lamivudine is a rare cause of liver test abnormalities or clinically apparent liver injury in patients with HIV infection without hepatitis B. Although several instances of lactic acidosis with hepatic steatosis and liver failure have been reported in patients receiving lamivudine, in all instances other nucleoside analogues more clearly associated with mitochondrial injury [didanosine, stavudine, zalcitrabine, zidovudine] were also being taken. No convincing instances of lactic acidosis with microvesicular fat have been reported in patients with hepatitis B who typically receive lamivudine alone or in combination with adefovir or tenofovir.

Likelihood score: E (unlikely cause of clinically apparent liver injury although flares of hepatitis B can occur during or following therapy).

### Mechanism of Injury

The safety of lamivudine may relate to its minimal hepatic metabolism. In addition, lamivudine is an L-enantiomer as well as being blocked at the 3’ position of the deoxyribose, thus insuring that it is not used by either nuclear or mitochondrial host polymerases. Flares during or following therapy of HBV infection probably represent immune-mediated exacerbation of hepatitis B. Finally, in vitro lamivudine has little activity against mitochondrial polymerase gamma.

### Outcome and Management

Initial on-treatment flares of hepatitis B due to lamivudine are usually mild, asymptomatic and self-limited, not requiring modification of dose or discontinuation. In contrast, flares developing in association with antiviral resistance and withdrawal flares can be severe, accompanied by clinical symptoms and lead to liver decompensation and death or need for liver transplantation. For these reasons, patients who develop viral breakthrough should be followed carefully, and therapy should be replaced by or combined with an agent with a different profile of antiviral resistance. Patients who discontinue lamivudine therapy should be followed carefully and therapy reinitiated promptly if clinical symptoms or signs of severe relapse arise.

[Agents used in therapy of HBV infection include adefovir, emtricitabine, entecavir, lamivudine, telbivudine, tenofovir, interferon alfa and peginterferon.]

Drug Class: Antiviral Agents, Antiretroviral Agents, Hepatitis B Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Adefovir, Didanosine, Emtricitabine, Entecavir, Stavudine, Telbivudine, Tenofovir, Zidovudine

## CASE REPORTS

### Case 1. On treatment flare of hepatitis B shortly after starting lamivudine therapy.

[NIH Case: Lamivudine D6]

A 43 year old man with HBeAg-positive chronic hepatitis B was started on lamivudine (100 mg daily) and developed a mild flare in serum aminotransferase levels within a few weeks of starting therapy. He felt well and had no symptoms. He was taking no other medications or herbal products and did not drink alcohol. Physical examination was unchanged and unremarkable. Serum aminotransferase levels rose, but total bilirubin levels remained normal. A liver biopsy done before therapy had shown moderate activity and an incomplete cirrhosis (fibrosis score 5+ of a possible 6+). Lamivudine was continued at the same dose. Serum aminotransferase levels remained high for 6 weeks, but subsequently fell to near normal values. HBV DNA levels also decreased. In follow up, he remained HBeAg-positive and by 48 weeks of therapy developed antiviral resistance. He was later treated with the combination of lamivudine and adefovir with success, with loss of HBeAg and fall of HBV DNA levels to undetectable and ALT levels to normal.

#### Key Points

Medication: | Lamivudine 100 mg daily
Pattern: | Hepatocellular
Severity: | 1+
Latency: | 4 weeks
Recovery: | 12 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | ALT (U/L) | AST (U/L) | Bilirubin (mg/dL) | HBV DNA (copies/mL) | Other
0 | 140 | 90 | 1.1 | 2,360,000,000
2 weeks | 168 | 130 | 0.7 | 63,300,000
4 weeks | 248 | 166 | 1.1 | 4,900,000
8 weeks | 307 | 235 | 1.3 | 170,000 | Alk P normal
12 weeks | 202 | 111 | 0.8
16 weeks | 79 | 59 | 0.8
20 weeks | 53 | 46 | 0.8 | 20,000
24 weeks | 62 | 50 | 0.8 | 9,000
Normal | <42 | <35 | <1.2 | <100

#### Comment

Serum ALT and AST levels doubled and rose to greater than 8 times the upper limit of the normal range during the first 3 months of antiviral therapy. However, these changes occurred while HBV DNA levels were falling, and the patient remained asymptomatic and without jaundice. Transient and asymptomatic elevations of ALT and AST above baseline are common during the first 2-12 weeks of therapy of chronic hepatitis B with virtually all nucleoside analogues. The flare is suspected to indicate a renewed immunological response to HBV, triggered by the sudden fall in HBV DNA levels and inhibition of intracellular replication. These flares may be more prominent or more significant in patients with preexisting cirrhosis, but generally do not require dose modifications or discontinuation of therapy.

### Case 2. On treatment flare of hepatitis B upon development of lamivudine resistance.

[NIH Case: Lamivudine D1]

A 32 year old man was found to have abnormal liver tests when he applied for disability insurance. He was positive for hepatitis B surface and e antigen and had high serum aminotransferase and HBV DNA levels. He was minimally if at all symptomatic of liver disease, and physical examination was normal. A liver biopsy showed marked necroinflammatory activity and bridging hepatic fibrosis. He received a course of alpha interferon without a lasting response. He was then started on lamivudine (100 mg/day), whereupon serum ALT and HBV DNA levels fell promptly (Table). After 18 months, he was HBeAg-negative, but anti-HBe was not detected. After 4 years of lamivudine therapy, ALT levels were normal and repeat liver biopsy showed marked improvement. Six months later, however, while still on lamivudine, serum ALT levels began to rise and HBV DNA was again detectable in high levels. Molecular testing revealed lamivudine-resistant mutant (rtM204I) virus. He was later treated with tenofovir with prompt improvement in HBV DNA and ALT levels.

#### Key Points

Medication: | Lamivudine 100 mg daily
Pattern: | Hepatocellular
Severity: | 1+ (aminotransferase elevations without jaundice)
Latency: | 4 years
Recovery: | After switching to tenofovir therapy
Other medications: | None

#### Laboratory Values

Time After Starting | ALT (U/L) | Bilirubin (mg/dL) | HBV DNA (copies/mL) | Other
0 | 524 | 0.9 | 94,500,000 | Liver biopsy
1 month | 210 | 1.1 | 2,430,000
2 month | 32 | 1.1 | 2,000
12 months | 27 | 1.1 | 100
2 years | 20 | 0.9 | <100 | HBeAg negative
4 years | 20 | 0.6 | 200 | Biopsy
5 years | 259 | 1.1 | 157,800,000 | HBeAg positive
5.5 years | 1657 | 1.2 | 59,800,000 | rtM201I mutant
5.8 years | 81 | 1.0 | 37,120,000
6.5 years | 101 | 0.6 | 6,670,000
| Lamivudine stopped and tenofovir (300 mg daily) started
7.5 years | 56 | 1.0 | None detected | Still HBeAg positive
Normal | <42 | <1.2 | <100

#### Comment

Long term therapy of hepatitis B with lamivudine is associated with a high rate of antiviral resistance, particularly in patients with HBeAg and high levels of serum HBV DNA. Resistance usually arises in the first 2 years of therapy, but can arise at any time with long term treatment. Generally, HBV DNA levels begin to rise first, followed by increases in serum aminotransferase levels. Molecular testing shows the presence of mutations in the polymerase gene that are associated with resistance to the nucleoside analogue being used. The flare of hepatitis that accompanies development of antiviral resistance is often referred to as “breakthrough” and can be severe and even fatal, particularly in patients with preexisting, underlying cirrhosis. These features make monotherapy with lamivudine problematic in chronic hepatitis B and underscore the need to monitor patients on long term therapy carefully.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lamivudine – Epivir®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=lamivudine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lamivudine | 134678-17-4 | C8-H11-N3-O3-S | Lamivudine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 18 April 2019

Nunez M. Hepatotoxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-63. (Textbook of pharmacology and therapeutics).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
Freiman JP, Helfert KE, Hamrell MR, Stein DS. Hepatomegaly with severe steatosis in HIV-seropositive patients. AIDS 1993; 7; 379-85. (Reports of 6 fatal and 2 nonfatal cases of hepatomegaly and steatosis in patients with HIV on zidovudine for 3-12 months). 8471200
Chattha G, Arieff AI, Cumings G, Tierney LM Jr. Lactic acidosis complicating the acquired immunodeficiency syndrome. Ann Intern Med 1993; 118: 37-9. (Report of 7 patients with HIV infection who developed lactic acidosis of unknown cause, presenting with nausea, anorexia and weight loss followed by dyspnea, stupor and death [in 4]; 4 on zidovudine, 1 ganciclovir and 1 clofazimine; initial arterial pH 7.09-7.27, lactate 10.4-17.4 mmol/L). 8416156
McKenzie R, Fried MW, Sallie R, Conjeevaram H, Di Bisceglie AM, Park Y, Savarese B, et al. Hepatic failure and lactic acidosis due to fialuridine (FIAU), an investigational nucleoside analogue for chronic hepatitis B. N Engl J Med 1995; 333: 1099-105. (Description of syndrome of lactic acidosis, hepatic failure and pancreatitis arising after 8-11 weeks of fialuridine treatment in 15 patients with chronic hepatitis B; among 7 patients affected, 5 died of intractable lactic acidosis and 2 survived, but required emergency liver transplantation). 7565947
Lewis W, Dalakas MC. Mitochondrial toxicity of antiviral drugs. Nature Med 1995; 1: 417-23. (Review of mechanisms for mitochondrial injury by nucleoside analogues including inhibition of mitochondrial DNA polymerase gamma). 7585087
Styrt B, Freiman JP. Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am 1995; 24: 839-52. (Early review of liver toxicity of antiviral agents; covering the first four nucleoside analogues used for HIV infection: zidovudine, didanosine, zalcitabine and stavudine). 8749901
Honkoop P, de Man RA, Heijtink RA, Schalm SW. Hepatitis B reactivation after lamivudine. Lancet 1995; 346: 1156-7. (29 year old with chronic hepatitis B developed flare of hepatitis starting 4 weeks after 6 month course of lamivudine, with jaundice [peak bilirubin 7 mg/dL, ALT 3290 U/L] and high levels of HBV DNA, having rebounded after therapy). 7475613
Lenzo NP, Garas BA, French MA. Hepatic steatosis and lactic acidosis associated with stavudine treatment in an HIV patient: a case report. AIDS 1997; 11: 1294-6. (32 year old with HIV developed lactic acidosis and hepatic steatosis 6 months after starting stavudine [plus zidovudine and lamivudine] with bilirubin 1.6 mg/dL and ALT 67 U/L, rapid resolution with stopping stavudine). 9256950
Schiano T, Lissoos T, Ahmed A, Siano C, Zaitman D, Cohn G, Ehrenpreis E. Lamivudine-stavudine-induced liver failure in hepatitis B cirrhosis. Am J Gastroenterol 1997; 92: 1563-4. (Patient with HIV-HBV coinfection and cirrhosis developed flare of hepatitis beginning 2 weeks after adding lamivudine to long term stavudine; bilirubin rising to 20.7 mg/dL, ALT 2414 U/L, ascites and pruritus; slowly improving once lamivudine was stopped; HBV DNA level was high, but timing and serial results were not given). 9317091
Zylberberg H, Pialoux G, Carnot F, Landau A, Bréot C, Pol S. Rapidly evolving hepatitis C virus-related cirrhosis in a human immunodeficiency virus-infected patient receiving triple antiretroviral therapy. Clin Infect Dis 1998; 27:1255-8. (36 year old with HIV-HCV coinfection developed ascites 9 months after starting lamivudine, indinavir and stavudine with bilirubin 2.1 mg/dL, ALT 60 U/L, and Alk P 107 U/L, with subsequent liver failure; biopsy showed nodularity and "cirrhosis"). 9827279
Brinkman K, ter Hofstede HJ, Burger DM, Smeitink JAM, Koopmans PP. Adverse effects of reverse transcriptase inhibitors: mitochondrial toxicity as a common pathway. AIDS 1998; 12: 1735-44. (Review of mitochondrial function and role of mitochondrial toxicity or depletion in the adverse side effects of nucleoside analogues). 9792373
Bessesen M, Ives D, Condreay L, Lawrence S, Sherman KE. Chronic active hepatitis B exacerbations in human immunodeficiency virus-infected patients following development of resistance to or withdrawal of lamivudine. Clin Infect Dis 1999; 28: 1032-5. (Five patients with HIV-HBV coinfection had clinically apparent flares of hepatitis [ALT 163-1408 U/L, bilirubin 0.8-9.5 mg/dL] either on lamivudine [n=3; all 3 with lamivudine resistance] or upon withdrawal [n=2; when switched to other antiretrovirals without activity against HBV]; one died). 10452630
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA 2000; 283: 74-80. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection). 10632283
Velasco M, Guijarro C. Elevated liver enzymes following initiation of antiretroviral therapy. JAMA 2000; 283: 2526-7. (Letter in response to Sulkowski et al. [JAMA 2000] pointing out that antiretroviral therapy can cause immune reconstitution and flares of hepatitis B or C which may be misdiagnosed as hepatotoxicity). 10815112
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Elevated liver enzymes following initiation of antiretroviral therapy JAMA 2000; 283: 2526-7. (Reply to Velasco and Guijarro pointing at that the majority of the ALT elevations described could not be attributed to immune reconstitution). 10815113
Johri S, Alkhuja S, Siviglia G, Soni A. Steatosis-lactic acidosis syndrome associated with stavudine and lamivudine therapy. AIDS 2000; 14: 1286. (Three women with HIV infection developed lactic acidosis and hepatic steatosis 1-8 months after starting stavudine and lamivudine with AST 291, 48 and 119 U/L, severe acidosis, and fatty liver by imaging; two died one of whom had massive hepatomegaly and steatosis on autopsy). 10894300
Lonergan JT, Behling C, Pfander H, Hassanein TI, Mathews WC. Hyperlactatemia and hepatic abnormalities in 10 human immunodeficiency virus-infected patients receiving nucleoside analogue combination regimens. Clin Infect Dis 2000; 31: 162-6. (Over 6 months, authors identified 10 HIV-infected patients with high lactate levels [2.9-6.2 mmol/L]; all were taking stavudine, 5 didanosine and 7 lamivudine for 4-20 months; 8 with symptoms of abdominal pain, nausea or distension; all with ALT elevations [2-10.7 times ULN], 3 with HBV or HCV; imaging showed fatty liver in 5; all resolved with stopping, lactate levels falling to normal after 16-111 days). 10913415
Bruno R, Sacchi P, Malfitano A, Filice G. YMDD-mutant HBV strain as a cause of liver failure in an HIV-infected patient. Gastroenterology 2001; 121: 1027-8. (38 year old man with HIV-HBV coinfection on long term antiretroviral therapy including lamivudine [~4 years] developed jaundice with bilirubin 7.4 mg/dL, ALT 1658 U/L, normal lactate, INR 4 and HBV DNA of 270,000 copies/mL with lamivudine resistant mutations [rtM201I and rtL180M], progressive liver failure and death). 11665695
Mina J, Moore CB, James IR, Nolan D, Upton RP, McKinnon EJ, Mallal SA. Chronic hyperlactatemia in HIV-infected patients taking antiretroviral therapy. AIDS 2001; 15: 717-23. (349 patients with HIV infection were screened for lactate levels on multiple occasions; 2 had lactic acidosis and were both symptomatic and on stavudine: 3.9 per 1000 person-years). 11371686
Ormseth EJ, Holtzmuller KC, Goodman ZD, Colonna JO, Batty DS, Sjogren MH. Hepatic decompensation associated with lamivudine: a case report and review of lamivudine-induced hepatotoxicity. Am J Gastroenterol 2001; 96: 1619-22. (62 year old with HBV related cirrhosis developed severe flare starting 8 weeks after starting lamivudine [ALT rising from 171 to 1500 U/L, bilirubin 3.1 to 11 mg/dL while HBV DNA became undetectable]; variceal hemorrhage and progressive encephalopathy led to emergency liver transplant, after which lamivudine was continued and he remained HBsAg negative). 11374710
Cihlar T, Birkus G, Greenwalt DE, Hitchcock MJM. Tenofovir exhibits low cytotoxicity in various human cell types: comparison with other nucleotide reverse transcriptase inhibitors. Antiviral Research 2002; 54: 37.45. (In vitro study of nucleoside analogues found that tenofovir and lamivudine were less cytotoxic to several human cell types than zidovudine, stavudine, didanosine and zalcitabine). 11888656
Clark S, Creighton S, Portmann B, Taylor C, Wendon J, Cramp M. Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol 2002; 36: 295-301. (6 patients with HIV infection who developed acute liver failure on stavudine [n=5], lamivudine [n=3], didanosine [n=2], saquinavir [n=2], efavirenz [n=2], nevirapine [n=2], or nelfinavir, delaviridine or zidovudine [n=1] for 1-3 months [peak bilirubin 2.7-32 mg/dL, AST 240-8650 U/L, Alk P 122-191 U/L]; 2 with signs of hypersensitivity; two with hepatitis B; 5 died, autopsies showing massive necrosis; one with massive steatosis; likely multiple causes). 11830344
Spengler U, Lichterfeld M, Rockstroh JK. Antiretroviral drug toxicity.a challenge for the hepatologist? J Hepatol 2002; 36: 283-94. (Review of the diagnosis of drug induced liver disease in patients with HIV on antiretroviral agents, with discussion of mechanisms including mitochondrial toxicity and hypersensitivity reactions). 11830343
Bonnet F, Bonarek M, Morlat P, Mercie P, Dupon M, Gemain MC, Malvy D, et al. Risk factors for lactic acidosis in HIV-1-infected patients treated with nucleoside reverse-transcriptase inhibitors: a case-control study. Clin Infect Dis 2003; 36: 1324-8. (Case control study of 9 patients [5 women] with HIV infection and lactic acidosis, 6 with hepatomegaly and 5 with jaundice, 8 on stavudine, 7 on didanosine, 6 on zidovudine; 6 died; risk factors were renal insufficiency and low CD4 counts but numbers of cases were few). 12746780
Arenas-Pinto A, Grant AD, Edwards S, Weller IVD. Lactic acidosis in HIV-1 infected patients: a systematic review of published cases. Sex Transm Infect 2003; 79: 340-4. (Review of 217 published cases of lactic acidosis; 53% female, all taking at least one nucleoside for 1-36 months, 61% on stavudine, 33% didanosine, 31% zidovudine, 30% lamivudine; 92% had hepatic steatosis on biopsy or autopsy; 48% died). 12902594
Kontorinis N, Dieterich D. Hepatotoxicity of antiretroviral therapy. AIDS Rev 2003; 5: 36-43. (Review of hepatotoxicity of antiretroviral drugs; definition of hepatotoxicity in antiretroviral studies; grade 1=1.25-2.5 times, grade 2=2.6-5 times, grade 3=5.1-10 times and grade 4=>10 times normal or baseline ALT values; abacavir and lamivudine are least likely to cause hepatotoxicity). 12875106
Ogedegbe AE, Thomas DL, Diehl AM. Hyperlactataemia syndromes associated with HIV therapy. Lancet Infect Dis 2003; 3: 329-37. (Review of mechanisms of hyperlactatemia with antiretroviral therapy, occurs mostly with use of nucleoside analogues, stavudine, didanosine and zidovudine, attributed to mitochondrial depletion, but other mechanisms may be involved). 12781504
Ofotokun I, Pomeroy C. Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med 2003; 11: 55-9. (Review of sex differences in adverse events; higher frequency of mitochondrial toxicity and hypersensitivity in women than men). 12717043
Ogedegbe AO, Sulkowski MS. Antiretroviral-associated liver injury. Clin Liver Dis 2003; 7: 475-99. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommend monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated). 12879995
Lok AS, Lai CL, Leung N, Yao GB, Cui ZY, Schiff ER, Dienstag JL, et al. Long-term safety of lamivudine treatment in patients with chronic hepatitis B. Gastroenterology 2004; 126:1932-3. (Analysis of hepatitis flares in 998 patients treated with lamivudine for up to 6 years; during the first year, flares [ALT >3 times normal] were less common during lamivudine [10%] than placebo [19%] therapy, but increased thereafter usually in association with antiviral resistance; 8 patients developed hepatic decompensation and 2 with antiviral resistance died). 14724824
Abrescia N, D.Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. Hepatotoxicity of antiretroviral drugs. Curr Pharm Des 2005; 11: 3697-710. (Review of hepatotoxicity of antiretrovirals; major syndrome with nucleoside analogues is mitochondrial injury with lactic acidosis and severe hepatomegaly and steatosis). 16305505
Chang TT, Gish RG, de Man R, Gadano A, Sollano J, Chao YC, Lok AS, et al.; BEHoLD AI463022 Study Group. A comparison of entecavir and lamivudine for HBeAg-positive chronic hepatitis B. N Engl J Med 2006; 354: 1001-10. (Controlled trial comparing entecavir [n=354] to lamivudine [n=355] in patients with HBeAg-positive chronic hepatitis B; on-treatment ALT elevations >5 times normal in 10% of entecavir- vs 17% of lamivudine-treated subjects [entecavir therapy stopped in one patient]; posttreatment elevations in 2% vs 12%). 16525137
Lai CL, Shouval D, Lok AS, Chang TT, Cheinquer H, Goodman Z, DeHertogh D, et al.; BEHoLD AI463027 Study Group. Entecavir versus lamivudine for patients with HBeAg-negative chronic hepatitis B. N Engl J Med 2006; 354: 1011-20. (Controlled trial comparing entecavir [n=325] to lamivudine [n=313] in patients with HBeAg-negative chronic hepatitis B; on-treatment ALT elevations >5 times normal in 2% of entecavir- vs 3% of lamivudine-treated; posttreatment elevations in 12% vs 29%, no deaths from flares). 16525138
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Among 4690 reports of fatal acute liver failure due to medications reported to a WHO data, 80 were attributed to lamivudine which ranked 6th, even though the lamivudine was probably being given for the acute liver failure rather than causing it). 16054882
Lai CL, Gane E, Liaw YF, Hsu CW, Thongsawat S, Wang Y, Chen Y, et al.; Globe Study Group. Telbivudine versus lamivudine in patients with chronic hepatitis B. N Engl J Med 2007; 357: 2576-88. (Trial of telbivudine [600 mg/day] vs lamivudine [100 mg/day] for 52 weeks in 1370 patients with chronic hepatitis B; ALT >3 times ULN in 3.7% of telbivudine, 6.3% of lamivudine; 1 on lamivudine developed antiviral resistance and liver failure requiring liver transplant). 18094378
Jain MK. Drug-induced liver injury associated with HIV medications. Clin Liver Dis 2007; 11: 615-39, vii-viii. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], cholestatic hepatitis [many agents]). 17723923
Hou J, Yin YK, Xu D, Tan D, Niu J, Zhou X, Wang Y, et al. Telbivudine versus lamivudine in Chinese patients with chronic hepatitis B: Results at 1 year of a randomized, double-blind trial. Hepatology 2008; 47: 447-54. (Trial of telbivudine vs lamivudine for 52 weeks in 332 patients with hepatitis B; ALT elevations >3 times normal occurred in 9.1% of lamivudine vs 5.4% of telbivudine treated subjects, usually associated with viral breakthrough; none fatal). 18080339
Schiff E, Simsek H, Lee WM, Chao YC, Sette H Jr, Janssen HL, Han SH, et al. Efficacy and safety of entecavir in patients with chronic hepatitis B and advanced hepatic fibrosis or cirrhosis. Am J Gastroenterol 2008; 103: 2776-83. (Analysis of 245 patients with advanced chronic hepatitis B in 3 clinical trials; on-treatment flares [ALT >10 times normal] occurred in 1 of 120 entecavir- vs 4 of 125 lamivudine-treated patients). 18721244
Hammer SM, Eron JJ Jr, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al.; International AIDS Society-USA. Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA 2008; 300: 555-70. (Recommendations on use of antiviral therapy in adults with HIV infection, including use of recently approved agents: raltegravir, maraviroc and etravirine). 18677028
Inductivo-Yu I, Bonacini M. Highly active antiretroviral therapy-induced liver injury. Current Drug Safety 2008; 3: 4-13. (Review of drug induced liver injury due to antiretroviral agents). 18690975
Soriano V, Puoti M, Garcia-Gascó Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. Antiretroviral drugs and liver injury. AIDS 2008; 22: 1-13. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes; problematic agents include didanosine, stavudine and zidovudine, nevirapine and efavirenz, full dose ritonavir and tipranavir). 18090386
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirez and 4 miscellaneous combinations but none to lamivudine). 18955056
Fontana RJ. Side effects of long-term oral antiviral therapy for hepatitis B. Hepatology 2009; 49 (5 Suppl): S185-95. (Review of side effects of nucleoside analogues used to treat chronic hepatitis B). 19399802
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 40 cases, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, including 3 to combinations with stavudine and 1 to abacavir, but none were attributed to lamivudine). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 ; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to lamivudine or other antivral agents used to treat hepatitis B). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, two of which were attributed to lamivudine but both in combination with zidovudine to treat HIV infection). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] were attributed to antiretroviral agents but none were due to lamivudine or agents being used to treat hepatitis B). 25754159
Lee KS, Kweon YO, Um SH, Kim BH, Lim YS, Paik SW, Heo J, et al. Efficacy and safety of entecavir versus lamivudine over 5 years of treatment: A randomized controlled trial in Korean patients with hepatitis B e antigen-negative chronic hepatitis B. Clin Mol Hepatol 2017; 23: 331-9. (Among 120 Korean patients with chronic hepatitis B treated with lamivudine or entecavir for at least 2 years, virologic responses were less common with lamivudine [48% vs 95%] while breakthough was more frequent [43% vs 1%]; serious adverse events were rare and were unrelated to therapy). 28946736
Pan CQ, Yi W, Liu M, Wan G, Hu YH, Zhou MF. Lamivudine therapy during the second vs the third trimester for preventing transmission of chronic hepatitis B. J Viral Hepat 2017; 24: 246-52. (Among 160 HBsAg positive expectant mothers with high levels of HBV DNA who were treated with lamivudine starting in the 2nd or 3rd trimester of pregnancy, none had evidence of transmission of hepatitis B to their newborns, while ALT flares occurred in 3% during pregnancy and 9% postpartum when lamivudine was stopped, but none had severe hepatitis or acute liver failure). 28025872
Triumeq--a 3 drug combination for HIV. Med Lett Drugs Ther 2015; 57 (1459): 7-8. (Concise review of the clinical effiacy, safety and costs of the fixed dose combination of lamivudine, abacavir and dolutegravir as a single tablet regimen for HIV infection; mentions common adverse events of insomnia, headahce and fatigue and that ALT and AST elevations can occur in patients with HBV or HCV coinfection). 25555073
Cahn P, Madero JS, Arribas JR, Antinori A, Ortiz R, Clarke AE, Hung CC, Et al.; GEMINI Study Team. Dolutegravir plus lamivudine versus dolutegravir plus tenofovir disoproxil fumarate and emtricitabine in antiretroviral-naive adults with HIV-1 infection (GEMINI-1 and GEMINI-2): week 48 results from two multicentre, double-blind, randomised, non-inferiority, phase 3 trials. Lancet 2019; 393 (10167): 143-55. (Among 1441 patients with HIV infection enrolled in two controlled trials comparing 2-drug [dolutegravir and lamivudine] to 3-drug [dolutegravir, tenofovir, emtricitabine] regimens, virologic response rates were similar [91% vs 93%] while drug related adverse events were less frequent with the 2-drug regimen [18% vs 24%], but serious events were similar in frequency [1% vs 1%]. 30420123

## OTHER REFERENCE LINKS

1. Recent References on Lamivudine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lamivudine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lamivudine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lamivudine)